# Germander

## OVERVIEW

### Introduction

Germander refers to about 250 species of plants in the mint family (genus: Teucrium) used for centuries in herbal teas and more recently marketed as a germander extract as an aid for weight control and management of diabetes and hyperlipidemia. Germander extracts have been linked to multiple instances of clinically apparent liver injury which can be severe and lead to fatality.

### Background

Germander is derived from aerial parts of a perennial aromatic plant of the mint family (Teucrium Lamiaceae) which has been used in Europe for centuries to treat inflammatory and digestive disorders. Germander is also widely used in gardening for its attractive flowers and uniform shape. Only some species have been used as herbal medications. Germander (Teucrium chamaedrys) was purported to be beneficial in inflammatory conditions including fever, arthritis, gout and digestive complaints. Extracts of germander were developed and marketed in capsules of 600 mg in Europe as a weight loss and cholesterol lowering agent in the late 1980s. However, multiple reports of hepatotoxicity from germander (including from both pill form as well as in tea) led to its ban as an herbal medication in many countries. Nevertheless, raw germander remains available in some countries and other Teucrium L. species have been used as herbal medications and teas and have been linked to cases of liver injury.

### Hepatotoxicity

Liver injury attributable to germander was first reported in a series of publications from France in 1992, a few years after a weight loss supplement containing germander ("Tealine") was commercially marketed in that country. The onset of acute injury varied from 2 to 18 weeks (averaging 9 weeks) after starting germander capsules or tea. The typical presentation was with fatigue, nausea and jaundice in an acute viral hepatitis-like syndrome with a hepatocellular pattern of serum enzyme elevations. Immunoallergic features were uncommon or minimal as were autoantibodies. Liver biopsies showed a prominence of centrilobular necrosis and inflammation with minimal fibrosis. Most patients recovered rapidly upon withdrawal of germander, but a few fatalities were reported. Rapid recurrence with reexposure was reported on multiple occasions. A second pattern of injury was identified with longer term therapy, generally after 6 to 9 months of treatment, characterized by a chronic hepatitis-like syndrome often with arthralgias and fever and low levels of autoantibodies and hyperglobulinemia, with liver biopsy showing chronic hepatitis and fibrosis. Germander was banned in several European countries and was never marketed to a major extent in the United States. Other species of Teucrium (polium, capitatum, viscidum) have been implicated in causing similar hepatocellular injury clinically and histologically. Germander has been reported to be an adulterant of other herbal preparations including skullcap. Finally, germander has been implicated in liver injury, even when used to brew herbal teas. Because germander has been banned as a commercial extract, most recent cases have been due to brewing tea from leaves of locally collected germander plants.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

Germander and other Teucrium extracts have many components including glycosides, flavonoids, saponins, volatile oils and furan containing neoclerodane diterpenoids, the last of which (Teucrin A and Teuchmaedryn A) are considered the hepatotoxins responsible for its liver injury. The furano neoclerodane diterpenoids are oxidized by the cytochrome P450 system to reactive metabolites that covalently bind to proteins, deplete glutathione and cause cell disruption (in hepatocyte cell culture). Thus, germander may be a direct hepatotoxin causing injury in a manner similar to acetaminophen overdose and attributable to use of the purified extract in higher doses for longer periods than with traditional use of the herb. On the other hand, the frequent rapid recurrence on restarting germander (even a different preparation) argues in favor of an immunologically mediated injury. Ironically, extracts of Teucrium have antioxidant effects and decrease liver injury in several animal models.

### Outcome and Management

Hepatotoxicity from germander and other Teucrium extracts or tea preparations is usually self-limiting once the herbal is discontinued. Nevertheless, several cases of acute liver failure and death or liver transplantation after germander use have been reported as well as several instances of chronic hepatitis and cirrhosis. Germander has not been linked to vanishing bile duct syndrome. Because germander toxicity is associated with glutathione depletion in animal models, administration of N-acetylcysteine may be appropriate for acute, clinically apparent cases of hepatotoxicity. Recurrence upon rechallenge is common and should be avoided.

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. Acute self-limited hepatitis due to germander.

[Modified from Case 1: Pauwels A, Thierman-Duffaud D, Azanowsky JM, Loiseau D, Biour M, Levy VG. [Acute hepatitis caused by wild germander. Hepatotoxicity of herbal remedies. Two cases]. Gastroenterol Clin Biol 1992; 16: 92-5. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1537487)]

A 28 year old woman developed fatigue followed by jaundice 12 weeks after starting germander (620 mg daily) for weight loss. She had no previous history of liver disease and did not drink alcohol. She denied taking prescription medications and did not tell her physicians about the herbal use. Laboratory tests showed serum bilirubin of 9.6 mg/dL with marked elevations in ALT [35 times ULN], but minimal increase in alkaline phosphatase [1.4 times ULN]. Other causes of acute hepatitis were not found and abdominal ultrasound showed no abnormalities. Her symptoms resolved rapidly and all liver tests were normal one month after she stopped the herbal preparation (Table). Several years later, she restarted germander in combination with ephedra (500 mg/day) for weight loss, but developed nausea and fatigue within 2 to 3 weeks. Examination showed jaundice but no rash, fever or signs of chronic liver disease. Laboratory tests again showed elevations in serum bilirubin (6.1 mg/dL) and ALT (10 times ULN), with minimal increases in alkaline phosphatase (1.5 times ULN). There was no eosinophilia and the prothrombin time was normal. Tests for hepatitis A and B, cytomegalovirus, herpes simplex and human immunodeficiency virus infection were negative as were routine autoantibodies. Abdominal ultrasound was again normal. She was advised to stop the herbals. Over the next month, her symptoms and laboratory tests abnormalities resolved completely.

#### Key Points

Medication: | Germander (620 mg daily)
Pattern: | Hepatocellular (R=25 initially, 6.7 on reexposure)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Initially 12 weeks, on restarting 2-3 weeks
Recovery: | 1 month
Other medications: | On second occasion, ephedra

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (Times ULN) | Alk P (Times ULN) | Bilirubin (mg/dL) | Other
0 | Germander (620 mg daily) started for weight loss
12 weeks | 0 | 35 | 1.4 | 9.6 | Admission
14 weeks | 2 weeks | 10 | | 2.9
20 weeks | 8 weeks | 5 | | 1.6
6 months | 3 months | 1 | 1
Weeks After Restarting | 2 years later, Germander and Ephedra started for weight loss
3 weeks | 0 | 10 | 1.5 | 6.1 | Readmission
6 weeks | 3 weeks | 3.7 | | 3.6
12 weeks | 9 weeks | 0.9 | 0.7 | 0.6
Normal Values | | <1.0 | <1.0 | <1.2

#### Comment

This was the initial report of germander hepatotoxicity and was typical of the average case, with onset after 12 weeks with an acute viral hepatitis-like presentation of fatigue and jaundice, markedly hepatocellular pattern of serum enzyme elevations, and rapid resolution with stopping therapy. Also typical was the more rapid recurrence and similar pattern of injury on restarting the herbal preparation. Finally, the patient did not reveal the herbal use during the initial episode, and despite its obvious link to the liver injury chose to restart the product in an attempt to induce weight loss. There is little evidence that germander causes weight loss, but there is clear evidence that it is hepatotoxic.

### Case 2. Chronic hepatitis due to germander.

[Modified from Case 1: Ben Yahia M, Mavier P, Métreau JM, Zafrani ES, Fabre M, Gatineau-Saillant G, Dhumeaux D, Mallat A. [Chronic active hepatitis and cirrhosis induced by wild germander. 3 cases]. Gastroenterol Clin Biol 1993; 17: 959-62. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8125230)]

A 47 year old man developed fever, arthralgias and jaundice approximately 5 months after starting an herbal regimen for his diabetes consisting of daily tea with germander and other herbs. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Laboratory tests on initial presentation showed a total bilirubin of 6.3 mg/dL with marked elevations in serum ALT (50 times ULN), mild elevation in GGT (3 times ULN), but normal alkaline phosphatase and prothrombin time. White blood cell counts showed a mild eosinophilia (770/μL). Tests for hepatitis A, B and C were negative as were autoantibodies. Jaundice resolved rapidly and serum enzymes improved, but remained elevated (2-5 times ULN) for over a year. A liver biopsy showed chronic hepatitis with portal and periportal fibrosis with centrilobular and bridging necrosis. On referral for further evaluation, his chronic ingestion of herbal tea was discovered. Within 3 weeks of stopping the preparation, serum ALT levels fell into the normal range.

#### Key Points

Medication: | Germander (650 mg daily) tea
Pattern: | Hepatocellular (R=50)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5 months
Recovery: | Enzymes normal 3 weeks after stopping
Other medications: | Other botanicals in the tea preparation included geranium, myrrh, blueberry, eucalyptus, bog bean, walnut, nettle, piquant nettle, and willow

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (Times ULN) | GGT (Times ULN) | Bilirubin (mg/dL) | Other
5 months | 0 | 50 | 3 | 6.3 | Fever, arthralgias, jaundice
10 months | 0 | 42 | 10 | Normal
20 monhts | 0 | 5 | 2 | Normal | Liver biopsy
2 years | 0 | 4 | 1 | Normal
2.5 years | 0 | 4 | 3 | Normal | History of herbal use obtained
| | Herbal tea with germander stopped
31 months | 3 weeks | 1 | 1 | Normal
Normal Values | | <1.0 | <1.0 | <1.2

#### Comment

Drugs that can cause an acute viral hepatitis-like syndrome are often also capable of causing a chronic hepatitis pattern when given in low doses chronically (examples being methyldopa, nitrofurantoin and minocycline). The chronic hepatitis may resemble autoimmune hepatitis, but generally resolves once the agent is discontinued. Germander appears to share this characteristic, the chronic hepatitis developing in situations in which the herbal is continued despite evidence of hepatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Germander – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Germander | ID: 0977081085 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 12 March 2018

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; mentions that germander has been implicated in at least 35 cases of hepatotoxicity, 2 of which were fatal and 4 causing chronic hepatitis).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that germander was marketed in France starting in 1986 and widely used for weight control, but was then banned after reports of hepatotoxicity including acute and chronic hepatitis and liver failure were reported; mechanism of injury appears to be metabolic activation to a toxic intermediate [furan-containing neoclerodane diterpenoids]).
Germander. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007, pp 363-4. (Compilation of short monographs on herbal medications and dietary supplements).
Pauwels A, Thierman-Duffaud D, Azanowsky JM, Loiseau D, Biour M, Levy VG. [Acute hepatitis caused by wild germander. Hepatotoxicity of herbal remedies. Two cases]. Gastroenterol Clin Biol 1992; 16: 92-5. French. (Initial report of 2 cases of acute hepatitis caused by germander; 28 and 56 year old women who developed jaundice 6-12 weeks after starting germander [bilirubin 3.0-9.6 mg/dL, ALT 35-45 times ULN, Alk P 0.6-1.4 times ULN], resolving in 4-10 weeks, recurrence in one patient 3 weeks after restarting: Case 1). 1537487
Larrey D, Vial T, Pauwels A, Castot A, Biour M, David M, Michel H. Hepatitis after germander(Teucrium chamaedrys) administration: another instance of herbal medicine hepatotoxicity. Ann Intern Med 1992; 117: 129-32. (Concise summary of 7 cases of germander hepatotoxicity from France; 6 women and 1 man, ages 15 to 56 years, developing jaundice after taking germander capsules or tea for 3 to 18 weeks [bilirubin 4.0-27.7 mg/dL, ALT 9-61 times ULN, Alk P 0.5-3 times ULN], resolving in 1.5 to 6 months; 3 were reexposed and all had recurrence with jaundice, all ultimately recovered). 1605427
Castot A, Larrey D. [Hepatitis observed during a treatment with a drug or tea containing Wild Germander. Evaluation of 26 cases reported to the Regional Centers of Pharmacovigilance]. Gastroenterol Clin Biol 1992; 16: 916-22. French. (Summary of 26 patients who developed acute hepatitis while taking germander reported to French registry system; 25 women, 1 man, ages 14 to 59 years, taking germander for weight loss or digestive complaints, mostly using Tealine or Arkogelule, for 2-18 weeks, all with a hepatocellular pattern of liver enzymes [ALT 9 to 150 times ULN], almost all with jaundice and fatigue, one with pruritus, 5 with prolonged protime, 4 of 17 with low titers of autoantibodies, biopsies showing centro- or pan-lobular necrosis, all resolving within 6 to 24 weeks, 12 with positive rechallenge). 1493896
Diaz D, Ferroudji S, Heran B, Barneon G, Larrey D, Michel H. [Fulminant hepatitis caused by wild germander]. Gastroenterol Clin Biol 1992; 16: 1006-7. French. (35 year old woman developed nausea and abdominal pain 5 to 6 weeks after starting germander tea 4 times daily [bilirubin 17.8 rising to 29.2 mg/dL, ALT 48 times ULN, prothrombin 18%], resolving within 3 months of stopping). 1493887
Legoux JL, Maitre F, Labarrière D, Gargot D, Festin D, Causse X. [Cytolytic hepatitis and wild Germander: a new case with reintroduction]. Gastroenterol Clin Biol 1992; 16: 813-5. French. (A 36 year old woman developed fever, nausea and arthralgias 8 months after starting Tealine [900 mg of germander daily] and green tea [1500 mg daily], without jaundice [bilirubin 1.8 mg/dL, ALT 22 times ULN, Alk P normal], resolving in 3 months and recurring within 8 days of restarting another brand of germander [bilirubin 4 mg/dL, ALT 6 times ULN, Alk P normal], resolving in 6 months). 1478415
Mattei A, Bizollon T, Charles JD, Debat P, Fontanges T, Chevallier M, Trepo C. [Liver damage induced by the ingestion of a product of phytotherapy containing wild germander. Four cases]. Gastroenterol Clin Biol 1992; 16: 798-800. French. (Four cases of hepatitis due to germander; 3 women, 1 man, ages 15 to 53 with onset after 2 to 4 months, 3 with jaundice [bilirubin 2.0-19.6 mg/dL, ALT 10-80 times ULN, Alk P 1-2 times ULN], resolving in 2-3 months, 1 with recurrence on rechallenge). 1478408
Mostefa-Kara N, Pauwels A, Pines E, Biour M, Levy VG. Fatal hepatitis after herbal tea. Lancet 1992; 340 (8820): 674. (68 year old woman developed jaundice while taking a second course of “Tealine” which contains wilder germander [bilirubin 18.2 mg/dL, ALT 225 U/L, Alk P 80 U/L, prothrombin index 18%], with progressive hepatic failure and death 2 weeks later). 1355234
Dao T, Peytier A, Galateau F, Valla A. [Chronic cirrhogenic hepatitis induced by germander]. Gastroenterol Clin Biol 1993; 17: 609-10. French. (54 year old woman developed jaundice 4 months after starting daily use of germander tea [bilirubin 7.9 rising to 23.9 mg/dL, ALT 55 times ULN, Alk P 2.1 times ULN], with persistence of lesser abnormalities during long term, infrequent use [bilirubin 1.6-2.7 mg/dL, ALT 2.5-10.4 times ULN, Alk P 1-2.2 times ULN], with ascites and biopsy showing cirrhosis, enzymes improving on stopping). 8253327
Ben Yahia M, Mavier P, Métreau JM, Zafrani ES, Fabre M, Gatineau-Saillant G, Dhumeaux D, Mallat A. [Chronic active hepatitis and cirrhosis induced by wild germander. 3 cases]. Gastroenterol Clin Biol 1993; 17: 959-62. French. (3 cases of chronic liver injury attributed to germander; 2 women and 1 man, ages 37-47 years, developed fever, arthralgias and jaundice ~6 months after starting germander [bilirubin 6.3, 2.3 and 15.6 mg/dL, ALT 20-50 times ULN, Alk P 1-3 times ULN], biopsies showing chronic hepatitis with fibrosis or cirrhosis, enzymes improving rapidly on stopping herbal). 8125230
Loeper J, Descatoire V, Letteron P, Moulis C, Degott C, Dansette P, Fau D, Pessayre D. Hepatotoxicity of germander in mice. Gastroenterology 1994; 106: 464-72. (Concentrated furano neo-clerodane diterpenoids isolated from germander tea induced midzonal liver cell necrosis in mice, which was prevented by inhibition of CYP 3A activity and worsened by glutathionine depletion). 8299912
Mattei A, Rucay P, Samuel D, Feray C, Reynes M, Bismuth H. Liver transplantation for severe acute liver failure after herbal medicine(Teucrium polium) administration. J Hepatol 1995; 22: 597. (37 year old Greek woman developed jaundice 5 days after a second 10 day use of Teucrium polium tea [bilirubin rising to 30.9 mg/dL, ALT 150 times ULN, Alk P 198, prothrombin 21%], undergoing liver transplantation, explant showing massive necrosis). 7650341
Lekehal M, Pessayre D, Lereau JM, Moulis C, Fouraste I, Fau D. Hepatotoxicity of the herbal medicine germander: metabolic activation of its furano diterpenoids by cytochrome P450 3A depletes cytoskeleton-associated protein thiols and forms plasma membrane blebs in rat hepatocytes. Hepatology 1996; 24: 212-8. (The furano diterpenoids of germander was toxic to isolated hepatocytes, the injury being blocked by inhibition of CYP3A and enhanced by glutathione depletion). 8707265
Laliberté L, Villeneuve JP. Hepatitis after the use of germander, a herbal remedy. CMAJ. 1996; 154: 1689-92. (Two cases of germander hepatotoxicity from Canada; 55 and 45 year old women taking extract for 6 months developed jaundice [bilirubin 13.9 and 3.5 mg/dL, ALT 1500 and 451 U/L, Alk P 164 and 79 U/L], resolving in 2 months; one had severe recurrence one week after restarting). 8646656
Cartagenes PRB, Moreira CC, Teixeira AC, Silveira FAA, Dias-Junior IB, Bichara CDA. [Hepatitis from sacaca(Croton Cajucara Benth): epidemiological and clinical features of 25 cases.] Gastroenterologia Endoscopia Digestiva 18(Supl 1): 24: 1999. Not in PubMed.
Stickel F, Egerer G, Seitz HK. Hepatotoxicity of botanicals. Public Health Nutr 2000; 3: 113-24. (Review of hepatotoxicity of herbal medications; germander is a member of the Labiatae family used for 2000 years as a remedy and considered safe, although components were unknown; large scale use resulted in large number of acute, chronic and even fulminant hepatitis cases in France; presumed cause are the furano neoclerodane diterpenoids). 10948380
Pérez Alvarez J, Sáez-Royuela F, Gento Peña E, López Morante A, Velasco Osés A, Martín Lorente J. [Acute hepatitis due to ingestion of Teucrium chamaedrys infusions]. Gastroenterol Hepatol 2001; 24:240-3. Spanish. (Two cases of hepatotoxicity due to germander: 70 year old man developed jaundice 6 months after starting herbal tea containing T. chamaedrys [bilirubin 8.5 mg/dL, ALT 1846 U/L, Alk P ~2 times ULN], resolving in 3 months; 49 year old woman developed jaundice 7 months after starting herbal tea with T. chamaedrys [bilirubin 18.7 mg/dL, ALT 1444 U/L, Alk P ~1.6 times ULN] resolving within 4 months). 11412592
Dourakis SP, Papanikolaou IS, Tzemanakis EN, Hadziyannis SJ. Acute hepatitis associated with herb(Teucrium capitatum L.) administration. Eur J Gastroenterol Hepatol 2002; 14: 693-5. (62 year old man developed jaundice 4 months after starting Teucrium capitatum containing herbal tea [bilirubin 21.4 mg/dL, ALT 1400 U/L, Alk P 177 U/L, ANA 1:640], resolving within 9 weeks with disappearance of ANA positivity). 12072605
Polymeros D, Kamberoglou D, Tzias V. Acute cholestatic hepatitis caused by Teucrium polium (golden germander) with transient appearance of antimitochondrial antibody. J Clin Gastroenterol 2002; 34: 100-1. (70 year old woman developed jaundice after 3 months of taking a Teucrium polium extract [bilirubin 38 mg/dL, ALT 1321 U/L, Alk P 318 U/L, AMA 1:160], resolving in 3 weeks and AMA becoming negative). 11743258
De Smet PAGM. Herbal remedies. N Engl J Med 2002; 347: 2046-56. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions). 12490687
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions). 12016550
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation). 12879994
Mazokopakis E, Lazaridou S, Tzardi M, Mixaki J, Diamantis I, Ganotakis E. Acute cholestatic hepatitis caused by Teucrium polium L. Phytomedicine 2004; 11: 83-4. (67 year old man developed jaundice 6 months after starting Teucrium polium tea [bilirubin 11.4 mg/dL, ALT 1272 U/L, Alk P 190 U/L, eosinophils 7%], resolving within 1 month of stopping). 14971726
Soares M do CP. Would Sacaca, Croton cajucara Benth(Euphorbiaceae) be an hepatotoxic plant like Germander, Teucrium chamaedrys L.(Labiatae)? Rev Soc Bras Med Trop 2004; 37 Suppl 2: 96-7. (Sacara [Croton cajucara Benth] is a common Brazilian shrub, the bark and leaves of which are used in herbal medicine to treat diarrhea and diabetes and have been marketed for weight loss; sacara like Teucrium chamaedrys contains a furano diterpenoid [Crotonin] similar to that found in germander [Teucrin A], which may account for the recent large number of cases of hepatotoxicity attributed to Sacara). 15586905
Jorge OA, Jorge AD. Hepatotoxicity associated with the ingestion of Centella asiatica. Rev Esp Enferm Dig 2005; 97: 115-24. (Initial report of clinically apparent hepatotoxicity due to Centella asiatica which contains triterpenic saponsoides similar to Teucrim; 3 cases, all women, ages 49 to 61 years who developed jaundice 3-8 weeks after starting Centella for weight loss [bilirubin 2.5-15.1 mg/dL, ALT 324-1694 U/L, Alk P 472-503 U/L], one with autoantibodies, resolving in 1-2 months of stopping; recurrence within 2 weeks in one patient who restarted it). 15801887
Starakis I, Siagris D, Leonidou L, Mazokopakis E, Tsamandas A, Karatza C. Hepatitis caused by the herbal remedy Teucrium polium L. Eur J Gastroenterol Hepatol 2006; 18: 681-3. (70 year old man developed jaundice 1 month after starting daily ingestion of an herbal tea containing Teucrium polium [bilirubin 2.7 mg/dL, ALT 649 U/L, Alk P 121 U/L, ANA 1:80], resolving in 8 weeks [ANA negative]). 16702859
Savvidou S, Goulis J, Giavazis I, Patsiaoura K, Hytiroglou P, Arvanitakis C. Herb-induced hepatitis by Teucrium polium L.: report of two cases and review of the literature. Eur J Gastroenterol Hepatol 2007; 19: 507-11. (47 year old woman found to have high ALT levels having consumed Teucrium polium tea for 3 months [bilirubin 1.8 mg/dL, ALT 677 U/L, Alk P 132 U/L], worsening for a month and then resolving a month later; 64 year old woman developed jaundice after taking Teucrium polium tablets for 2 months [bilirubin 11.2 mg/dL, ALT 1260 U/L, Alk P 386 U/L, 5.7% eosinophils], worsening for 20 days and resolving a month later). 17489062
Seeff LB. Herbal hepatotoxicity. Clin Liver Dis 2007; 11: 577-96. (Review of herbal induced hepatotoxicity, with detail of specific herbal compounds including review of literature of germander hepatotoxicity). 17723921
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but no case was attributed to germander). 18955056
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, none due to germander). 19159172
Poon WT, Chau TL, Lai CK, Tse KY, Chan YC, Leung KS, Chan YW. Hepatitis induced by Teucrium viscidum. Clin Toxicol(Phila) 2008; 46: 819-22. (51 year old woman developed jaundice 3 days after using herbal tea containing Teucrium viscidum [which has a similar diterpenoid: Teucvin] [bilirubin 11.4 mg/dL, ALT 2620 U/L, Alk P 186 U/L], resolving in 2 months). 18608288
Herrera S, Bruguera M. [Hepatotoxicity induced by herbs and medicines used to induce weight loss]. Gastroenterol Hepatol 2008; 31: 447-53. (Review of the hepatotoxicity of weight loss agents, both prescriptions and herbals; discussion of the epidemic of hepatitis caused by wild germander in France). 18783691
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (Review of the hepatotoxicity of botanicals used for weight loss including green tea extracts [Exolise, Hydroxycut, The Right Approach], Ma Huang, usnic acid [LipoKinetix] and Teucrium chamaedrys [germander], capitatum and polium and other terpenoid containing compounds such as skullcap and Centella asiatica). 18318821
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; germander is listed as a potential hepatotoxin, but is not specifically discussed). 19826971
Mimidis KP, Papadopoulos VP, Baltatzidis G, Giatromanolaki A, Sivridis E, Kartalis G. Severe acute cholestasis caused by Teucrium polium. J Gastrointestin Liver Dis 2009; 18: 387-8. (51 year old man developed jaundice two months after starting aqueous extract of Tecurium polium [bilirubin 9.8 rising to 37.4 mg/dL, ALT 863 U/L, Alk P 147 U/L], worsening for 11 days and then resolving within the next few months). 19795041
Lin LZ, Harnly JM, Upton R. Comparison of the phenolic component profiles of skullcap (Scutellaria lateriflora) and germander (Teucrium canadense and T. chamaedrys), a potentially hepatotoxic adulterant. Phytochem Anal 2009; 20: 298-306. (Herbal extracts of skullcap [S. lateriflora] have occasionally been contaminated with germander [T chamaedrys], but mass spectrometry can separate the two by demonstration of phenylethanoid components of germander). 19402188
Sáenz De Miera Olivera I, Fernández Marcos C, Sáez-Royuela Gonzalo F. [Ingestion of Teucrium chamaedrys infusions: evidence of acute hepatitis after its reintroduction]. Gastroenterol Hepatol. 2009; 32: 70-1. Spanish. (41 year old man developed mild abdominal discomfort and ALT elevations during use of Teucrium chamaedrys herbal teas on two occasions [bilirubin normal, ALT 459 U/L, GGT 84 U/L, ANA negative], resolving in 3 months of stopping). 19174107
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals including usnic acid [2], thermoslim [1], Ma Huang [1], horny goat weed [1], black cohosh [1], Hydroxycut [1] and unspecified herbals [4]; germander not listed). 20949552
Goksu E, Kilic T, Yilmaz D. Hepatitis: a herbal remedy Germander. Clin Toxicol (Phila) 2012; 50: 158. (69 year old Turkish man developed jaundice 1 month after completing a 2 month course of daily ingestion of germander plant tea [bilirubin 3.8 mg/dL, ALT 1380 U/L, Alk P 152 U/L], resolving within 1 month). 22304375
Gori L, Galluzzi P, Mascherini V, Gallo E, Lapi F, Menniti-Ippolito F, Raschetti R, et al. Two contemporary cases of hepatitis associated with Teucrium chamaedrys L. decoction use: case reports and review of literature. Basic Clin Pharmacol Toxicol 2011; 09: 521-6. (A husband and wife, ages 66 and 65 years, developed fatigue and nausea after regular use of an herbal tea [bilirubin normal, ALT 340 and 155 U/L, GGT 50 and 180 U/L], which resolved within 3 months but recurred in both when they restarted the decoction; testing of the herb showed T. chamaedrys). 21848806
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 6 publications on germander [T. chamaedrys and polium]). 22928722
Sezer RG, Bozaykut A. Pediatric hepatotoxicity associated with polygermander (teucrium polium). Clin Toxicol (Phila) 2012; 50: 153. (2 twins who given tea made from Teurcrium polium in their infant formula daily presented with vomiting and abnormal liver tests [bilirubin 0.5 and 1.0 mg/dL, ALT 139 and 431 U/L], resolving within 4-5 weeks of stopping). 22295888
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury discusses the hepatotoxicity of germander). 23121117
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis 2014; 46: 264-9. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among 4 cases attributed to germander, all 4 rechallenges were scored as positive). 24315480
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances; does not include cases linked to germander). 23510966
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to germander). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity discusses Teucrium chamaedrys as an ingredient in popular slimming aids with more than 50 cases of toxic hepatitis linked to its use, largely from France and usually presenting after 2-3 months of use with an acute hepatocellular pattern of injury). 22477279
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that germander has been used as an antiinflammatory agent but also for weight loss and has been linked to many cases of hepatitis, some fatal). 24099027
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea extract). 24918129
Dag M, Özturk Z, Aydnl M, Koruk I, Kadayfç A. Postpartum hepatotoxicity due to herbal medicine Teucrium polium. Ann Saudi Med 2014; 34: 541-3. (3 women, ages 31 to 37 years, developed liver injury while taking Teucrium polium for dyspeptic symptoms during the last trimester or immediate postpartum period [bilirubin 14-23 mg/dL, ALT 1212-2397 U/L, Alk P 200-586 U/L]). 25971830
Nencini C, Galluzzi P, Pippi F, Menchiari A, Micheli L. Hepatotoxicity of Teucrium chamaedrys L. decoction: role of difference in the harvesting area and preparation method. Indian J Pharmacol 2014; 46: 181-4. (A man and woman, ages 64 and 65 years, developed severe hepatitis [bilirubin and Alk P not given, ALT above 5 times ULN] which resolved within 2 months, but recurred a month after restarting a decoction of Teucrium chamaedrys, made by boiling the flowering parts of the herb that they had collected locally). 24741190
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a known germander containing product). 25043597
Rossi S, Navarro VJ. Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol 2014; 12: 1069-76. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; does not discuss germander). 23924877
Navarro VJ, Lucena MI. Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis 2014; 34: 172-93. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, mentions that germander has been linked to many cases of hepatotoxicity presenting as acute or chronic hepatitis, cirrhosis and acute liver failure with massive necrosis). 24879982
Korth C. Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract 2014; 27: 567-72. (Review of liver injury due to selected HDS discusses the literature implicating kava, green tea, germander, pyrrolizidine alkaloids and Herbalife products). 25546878
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-532. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that there have been numerous reports of liver injury from germander). 25500423
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. 2015; 89: 851-65. (Extensive review of liver injury due to HDS mentions that germander is a well established cause of liver injury, and similar cases have been linked to other members of the Teucrium family such as T. polium and T. viscidum). 25680499
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were primarily attributed to germander: see Navarro [2014]). 25754159
Zheng EX, Navarro VJ. Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol 2015; 3: 93-8. (Review of literature on liver injury due to HDS products used for weight loss, focusing upon the case series of liver injury attributed to Herbalife, Hydroxycut and OxyELITE Pro products which was predominantly hepatocellular (acute hepatitis-like) and had a significant mortality rate; does not discuss germander). 26357638
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products does not discuss germander]). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26950122) (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Marcus DM. Dietary supplements: What's in a name? What's in the bottle? Drug Test Anal 2016; 8 (3-4): 410-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27072845) (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident").
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions that germander was the most frequently implicated herb in causing liver injury, listing 23 references of single case reports and case series). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic nerosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, pyrrolizidine alkaloids and proprietary multi-ingredint nutrition supplements [MINS]). 27842768
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al.; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically mentioning germander). 28555362

## OTHER REFERENCE LINKS

1. Recent References on Germander: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Germander+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Germander: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Germander)